# Beta Interferon

## OVERVIEW

### Introduction

Interferon beta (ß-1a and ß-1b) is a cytokine and belongs to a group of naturally occurring proteins which interact with cell surface receptors to produce intracellular antiviral, anti-proliferative, and immuno-modulatory effects. Recombinant forms of interferon beta are used commonly to prevent relapses in multiple sclerosis. Interferon beta is a well known cause of mild hepatic injury that occasionally can lead to severe liver injury with jaundice.

### Background

Interferon (in" ter feer' on) beta is a type I interferon produced by fibroblasts and macrophages in response to viral infection and antigenic stimuli. Interferon beta is structurally and antigenically distinct from interferon alfa, but they share cell surface receptors. Despite having a common receptor, the two interferons have different intracellular effects, acting through related but different pathways to trigger changes in gene expression that modulate innate and adaptive immune responses and antiviral pathways. Interferon beta was developed largely as an immunomodulatory agent and showed evidence of benefit in relapsing multiple sclerosis for which it was first approved for use in the United States in 1993. Its major indication is to reduce the frequency of clinical exacerbations. Currently, five forms of interferon beta are available, and are produced by recombinant DNA technology:

• Betaseron – interferon ß-1b, subcutaneous injection (250 mcg) every other day. Approved 1993.

• Extavia – interferon ß-1b, subcutaneous injection (250 mcg) every other day. Approved 1993

• Avonex – interferon ß-1a, intramuscular injection (30 mcg) once weekly. Approved 1996.

• Rebif – interferon ß-1a, subcutaneous injection (8.8 mcg, 22 mcg, 44 mcg) thrice weekly. Approved 2003.

• Plegridy – peginterferon ß-1a, subcutaneous injection (63, 94, 125 mcg) every 14 days. Approved 2014.

The various forms of beta interferon are provided as a lyophilized powder for reconstitution or as a solution in single dose vials or in prefilled syringes, pens or autoinjectors. They differ in specific activity and pharmacokinetics and thus are used in different doses and regimens. Peginterferon ß-1a consists of recombinant beta interferon covalently linked to polyethylene glycol which makes it a larger protein molecule with a longer half-life and duration of action. Therapy is routinely given long term. Typical side effects include fatigue, muscle aches, headache, depression, fever and mild bone marrow suppression. Severe adverse events reported with use of beta interferon include hypersensitivity reactions, thrombotic microangiopathy, severe depression, suicidal thoughts and behaviors and autoimmune disorders.

### Hepatotoxicity

All five forms of interferon beta have been shown to cause hepatic injury, although most cases are asymptomatic and mild. The typical presentation is transient and mild elevations in serum aminotransferase levels occurring 3 to 12 months after starting therapy. Serum alkaline phosphatase levels are usually normal or minimally elevated, and symptoms and jaundice are rare. In prospective studies in which routine testing was applied, 20% to 40% of patients experienced at least one elevation in serum aminotransferase levels above 3 times the upper limit of normal. Elevations above 5 times the upper limit of normal occurred in 2% to 5% of recipients. This effect may be dose related and is more common when it is given daily or several times a week (compared to once weekly). Persistent ALT elevations suggestive of chronic hepatitis can occur and may require discontinuation of treatment (Case 1).

Liver injury with jaundice is rare (<1:1000 treated patient), but can be severe (Case 2) and even fatal (Case 3). In these rare cases, jaundice and symptoms usually appear 2 to 12 months after starting therapy, but the latency to onset is extremely variable and acute injury can arise after years of treatment. The liver injury is typically mild, but it can lead to prolonged jaundice or to acute liver failure. The clinical pattern is usually hepatocellular and resembles acute viral hepatitis or chronic hepatitis with an acute exacerbation. Fever, rash and eosinophilia are not common. Autoimmune features are somewhat common, but may relate more to the underlying multiple sclerosis rather than drug induced liver disease. Most reported cases have occurred in women. Rechallenge should be avoided in cases with jaundice. Cases of interferon-beta induced liver injury have become less frequent, probably because of the use of more modern, disease modifying agents for multiple sclerosis such as dimethyl fumarate, fingolimod, glatiramer acetate, ocrelizumab, and terflunomide.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from interferon beta is not known. The asymptomatic elevations in serum enzymes may be dose related. The cases with acute jaundice are occasionally associated with autoimmune features and may represent a triggering of an underlying autoimmune diathesis.

### Outcome and Management

The liver injury caused by interferon beta ranges from mild and transient serum enzyme elevations to clinically apparent liver injury with jaundice to rare instances of acute liver failure. In most cases, the injury usually resolves with discontinuation, sometimes with a delay of one to two weeks. Fatal cases have been reported. Rechallenge should be avoided in patients with jaundice, but may be tried cautiously in patients with serum enzyme elevations only; in this case, switching from one form of interferon beta to another (1a vs 1b) might be appropriate, although cross reactivity has been reported. The product labels for beta interferons recommend monitoring for liver test abnormalities and stopping therapy promptly if symptoms or jaundice arise.

Drug Class: Cytokine/Biologic Response Modifier, Multiple Sclerosis Agents

## CASE REPORTS

### Case 1. Asymptomatic aminotransferase elevations during interferon beta therapy.(1)

A 38 year old woman with multiple sclerosis was treated with interferon beta on several occasions during two of which she had asymptomatic serum aminotransferase elevations. Because of a relapse in her neurologic disease, she was retreated with interferon beta (ß-1b: Betaseron) 250 mcg weekly by subcutaneous injection. Serum enzymes were measured semi-annually and were mildly abnormal at 6 and more markedly elevated at 18 months. Interferon beta was stopped and enzyme levels decreased. However, she had a severe relapse in disease and was restarted on beta interferon with careful monitoring. Within two weeks, serum enzymes had risen and treatment was stopped again. Tests for hepatitis A, B and C and autoantibodies were negative, and CT scan of the abdomen showed no abnormalities. Because of persistence in enzyme elevations for 2 months, a liver biopsy was done which was read as normal. Other medications were continued, including gabapentin for neuropathy, bupropion for depression, nitrofurantoin for urinary tract infections and lansoprazole for reflux. In follow up one year later, serum enzyme tests had returned to pretreatment levels.

#### Key Points

Medication: | Interferon ß-1b (250 mcg thrice weekly)
Pattern: | Mixed (R=3.1)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | Initially 6 months, 11 days with reexposure
Recovery: | Delayed, but complete
Other medications: | Gabapentin, bupropion, nitrofurantoin, lansoprazole

#### Laboratory Values

Time Since Starting | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 35 | 147 | 0.2
Interferon beta started
6 months | 103 | 236 | 0.2
18 months | 310 | 254 | 0.4
Interferon beta stopped
Pre | 40 | 118 | 0.3
Interferon beta restarted
11 days | 366 | 322 | 0.4
Interferon beta stopped
1 month | 134 | 332 | 0.3
2 month | 263 | 276 | 0.3 | Liver biopsy normal
1 year later | 38 | 153 | 0.2
Normal Values | <45 | <130 | <1.2

#### Comment

This patient with multiple sclerosis developed recurrent asymptomatic serum enzyme elevations during several courses of interferon beta therapy. The alkaline phosphatase elevations were somewhat atypical for beta interferon induced liver injury, but mild elevations were present even before interferon was given. The patient was taking several other medications which can induce liver injury, but the liver abnormalities resolved despite continuation of these drugs. The liver biopsy indicated that there was no underlying chronic liver disease and that the drug induced liver injury was mild and not causing permanent injury or fibrosis. In cases such as this, retreatment with interferon beta might be considered if other options for management are exhausted. Careful monitoring of ALT and bilirubin levels is appropriate with discontinuation of interferon if ALT levels rise to above 10-fold elevated or either symptoms or jaundice arises. Switching from one form of interferon beta to another can be considered, but is unlikely to result in a different outcome. Use of a lower dose may also be appropriate. Switching to other modern disease-modifying medications for multiple sclerosis would be a more appropriate option.

### Case 2. Acute hepatocellular injury with jaundice attributed to interferon beta.(2)

A 46 year old woman with multiple sclerosis was started on interferon beta (ß-1a) in a dose of 30 mcg once weekly. After 3 months, serum aminotransferase levels were found to be elevated, and the medication was stopped. Two weeks later, she developed jaundice and underwent further evaluation. Tests for autoimmune liver disease (autoantibodies and immunoglobulin levels) and viral hepatitis were negative. Ultrasound of the liver was normal. A liver biopsy demonstrated changes suggestive of acute hepatitis with moderate inflammation and early fibrosis. She remained minimally symptomatic and was not hospitalized. Her other medications for hypertension were continued. Serum aminotransferase levels and jaundice resolved slowly, but all tests were normal in follow up 5 months later.

#### Key Points

Medication: | Interferon ß-1a (30 mcg intramuscularly once weekly)
Pattern: | Hepatocellular (R=27)
Severity: | 2+ (jaundice, not hospitalized)
Latency: | 3 months
Recovery: | Complete, 4-5 months after stopping
Other medications: | Hydrochlorothiazide, bisoprolol, zolpidem

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 9 | 50 | 0.5 | Baseline
0 | | Interferon beta started
100 | 0 | 850 | 91 | 0.7 | Routine testing
103 | 0 | Interferon beta stopped
117 | 14 | 1484 | 150 | 3.3 | Jaundice
122 | 18 | 1150 | 144 | 3.9
174 | 71 | 792 | 173 | 2.7 | Liver biopsy
240 | 137 | 18 | 100 | 0.5 | Follow up
Normal Values | | <42 | <115 | <1.2

#### Comment

In this lady, routine laboratory surveillance identified marked elevations in serum ALT levels approximately 3 months after starting therapy with interferon beta for multiple sclerosis. Interferon was stopped promptly, but liver test abnormalities continued to worsen for the next two weeks and she developed jaundice and mild symptoms of liver disease. Clinical history, laboratory tests, imaging studies and liver biopsy revealed no other cause for acute liver injury and the abnormalities resolved completely after treatment was stopped. This case was reviewed by an expert panel and judged as definite hepatotoxicity due to interferon beta with an acute self-limited course of mild-to-moderate (2+) severity. This patient should be cautioned against further exposure to interferon beta.

### Case 3. Acute liver failure arising during interferon beta therapy of multiple sclerosis.(3)

A 33 year old woman with multiple sclerosis, who was unresponsive to conventional therapy, was treated with interferon ß-1a in a dose of 44 mcg subcutaneously thrice weekly. Ten months after starting therapy, she developed fatigue followed by jaundice and clay-colored stools. She was found to have anasarca and severe jaundice and was hospitalized. Tests for hepatitis A, B and C and autoantibodies were negative, except for anti-phospholipid antibody. Ultrasound of the liver and ERCP were unrevealing. Liver biopsy demonstrated massive necrosis and was consistent with severe drug induced liver injury. She continued to deteriorate and was transferred to a liver transplant center where she was placed on corticosteroids and listed for transplant. While awaiting liver transplantation, she developed sepsis followed by multiple organ failure and death.

#### Key Points

Medication: | Interferon ß1a (44 mcg three times weekly)
Pattern: | Hepatocellular (R=24)
Severity: | 5+ (death)
Latency: | 10 months
Recovery: | Death
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | Beta interferon started
10 months | | Jaundice, fatigue, clay colored stools
| 1 day | Beta interferon stopped: hospitalized
| 3 days | 1,901 | 224 | 4.5 | INR 1.0
11 months | 4 weeks | 396 | 216 | 25.3 | Liver Biopsy
| 5 weeks | 374 | 274 | 21.1
| 7 weeks | 329 | 371 | 16.6 | Transfer
12 months | 8 weeks | 185 | 277 | 14.2 | INR 2.4
| 10 weeks | 102 | 161 | 19.2 | INR 2.6
| 11 weeks | 367 | 154 | 23.0 | INR 3.3
13 months | 12 weeks | 114 | 435 | 27.0 | INR 4.0
| 14 weeks | Death
Normal Values | | <42 | <116 | <1.2

#### Comment

This patient developed a severe, acute hepatitis-like clinical syndrome 10 months after starting therapy with interferon beta and died of progressive liver injury despite discontinuation of treatment as soon as jaundice was noted. Other causes of acute liver failure were excluded by history, laboratory tests, imaging and liver biopsy. While the relationship of this acute injury to interferon beta seems clear, acute liver failure in adults with multiple sclerosis can occur in the absence of an exciting factor. Use of corticosteroids in drug induced liver disease is controversial and usually limited to cases with clinical or laboratory findings suggestive of autoimmunity. In this case, anti-phospholipid antibody was considered adequate evidence. Because this patient did not undergo routine screening of serum enzymes during therapy, it is unclear whether indications for significant liver injury (marked ALT elevations) were present before the onset of jaundice and symptoms (as in Case 2).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Interferon Beta-1b – Betaseron® (Bayer HealthCare Pharmaceuticals)

Interferon Beta-1a – Avonex® (Biogen Idec), Rebif® (Serono)

DRUG CLASS

Cytokine/Biologic Response Modifier, Multiple Sclerosis Agents (https://www.ncbi.nlm.nih.gov/books/n/livertox/MultipleSclerosisAge/)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=interferon)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Interferon Beta-1a/1b | 220581-49-7 | Not available | Not available
Interferon Beta-1a | 145258-61-3 | Not available | Not available
Interferon Beta-1b | 145155-23-3 | Not available | Not available

## CITED REFERENCES

1 Fontana RJ, Hayashi P, Bonkovsky HL, Kleiner DE, Kochhar S, Gu J, Ghabril M. Presentation and outcomes with clinically apparent interferon beta hepatotoxicity. Dig Dis Sci 2013; 58: 1766-75. (Case 2.)
2 Fontana RJ, Hayashi P, Bonkovsky HL, Kleiner DE, Kochhar S, Gu J, Ghabril M. Presentation and outcomes with clinically apparent interferon beta hepatotoxicity. Dig Dis Sci 2013; 58: 1766-75. (Case 6.)
3 Fontana RJ, Hayashi P, Bonkovsky HL, Kleiner DE, Kochhar S, Gu J, Ghabril M. Presentation and outcomes with clinically apparent interferon beta hepatotoxicity. Dig Dis Sci 2013; 58: 1766-75. (Case 8.)

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2025

Abbreviations: MS, multiple sclerosis; CNS, central nervous system; ULN, upper limit of normal.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999; interferon beta is not discussed).
Krensky AM, Bennett WM, Vincenti F. Immunosuppressants, tolerogens, and immunostimulants. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1005-29. (Textbook of pharmacology and therapeutics; the effects of interferon beta in multiple sclerosis may relate to their ability to inhibit proliferation of T cells, block their movement into the CNS and to cause a shift in profile from pro- to anti-inflammatory types).
Ravandi F, Estrov Z, Kurzrock R, Breitmeyer JB, et al. A phase I study of recombinant interferon-beta in patients with advanced malignant disease. Clin Cancer Res 1999; 5: 3990-8. PIMD: 10632330 (Study of 34 patients with cancer given increasing doses of interferon beta-1a for 28 days; AST elevations occurred in 85%, ALT in 55%, particularly at higher doses; no clinically apparent liver injury).
Durelli L, Ferrero B, Oggero A, Verdun E, Bongioanni MR, Gentile E, Isoardo GL, et al. Autoimmune events during interferon beta-1b treatment for multiple sclerosis. J Neurol Sci 1999; 162: 74-83. PIMD: 10064173 (Monitoring for autoantibodies in 40 interferon beta-1b treated and 21 controls with multiple sclerosis; 32% of treated, but no control developed autoantibodies; usually present transiently and in low levels; 3 developed autoimmune thyroiditis).
Arbizu T, Alvarez-Cermeno JC, Decap G, Fernandez O, Garcia Merino A, Izquierdo G, et al. Interferon beta-1b treatment in patients with relapsing--remitting multiple sclerosis under a standardized protocol in Spain. Acta Neurol Scand 2000; 102: 209-17. PIMD: 11071104 (Analysis of Spanish database on 1419 patients with multiple sclerosis treated with interferon beta-1b, ALT elevations occurred in 0.5%, thyroid abnormalities in 0.4%).
Durelli L, Ferrero B, Oggero A, Verdun E, Ghezzi A, Montanari E, Zaffaroni M, et al.; Betaferon Safety Trial (BEST) Study Group. Liver and thyroid function and autoimmunity during interferon-beta 1b treatment for MS. Neurology 2001; 57: 1363-70. PIMD: 11673572 (Prospective study of 156 patients with multiple sclerosis treated with interferon beta-1b, found liver abnormalities in 4.6% at baseline, while 37.5% developed them on treatment; usually transient and within first 6 months; only 14% had ALT elevations more than 2 times ULN and no patient developed clinically apparent liver injury).
Yoshida EM, Rasmussen SL, Steinbrecher UP, Erb SR, Scudamore CH, Chung SW, Oger JJ, Hashiomoto SA. Fulminant liver failure during interferon beta treatment of multiple sclerosis. Neurology 2001; 56: 1416. PIMD: 11376205 (59 year old woman with multiple sclerosis developed nausea after 4 and jaundice after 6 weeks of interferon beta-1a [bilirubin 28.9 mg/dL, ALT 1360 U/L, Alk P 165 U/L, INR 8], ultimately requiring liver transplantation for acute liver failure).
Panitch H, Goodin DS, Francis G, Chang P, Coyle PK, O'Donnor P, Monaghan E, et al; EVIDENCE Study Group. Evidence of Interferon Dose-response: European North American Comparative Efficacy; University of British Columbia MS/MRI Research Group. Randomized, comparative study of interferon beta-1a treatment regimens in MS: The EVIDENCE Trial. Neurology 2002; 59: 1496-506. PIMD: 12451188 (Controlled trial of 2 regimens of interferon beta-1a in 676 patients with multiple sclerosis; ALT elevations occurred in 9-18%, but only 2% had ALT values greater than 5 times ULN and none developed clinically apparent hepatitis).
Duccini A. Autoimmune hepatitis and interferon beta-1a for multiple sclerosis. Am J Gastroenterol 2002; 97: 767-8. PIMD: 11922585 (38 year old woman developed jaundice 24 months after starting interferon beta-1a [bilirubin 18.7 mg/dL, ALT 1875 U/L, Alk P 221 U/L, protime 19.3 sec, SMA 1:80], treated with prednisone and ultimately recovered).
Tan FU, Cetinkaya H, Erden E, Ulkatan S, Aydin N. Dual benefit from intramuscular interferon-beta treatment in a patient with multiple sclerosis and chronic hepatitis-C virus infection. Hepatogastroenterology 2002; 49: 1686-7. PIMD: 12397766 (32 year old woman with both multiple sclerosis and hepatitis C appeared to have benefit to both conditions during interferon beta therapy).
Francis GS, Grumser Y, Alteri E, Micaleff A, O'Brien F, Alsop J, Moraga MS, et al. Hepatic reactions during treatment of multiple sclerosis with interferon-beta-1a: incidence and clinical significance. Drug Saf 2003; 26: 815-27. PIMD: 12908850 (Summary analysis of 6 controlled trials of interferon beta-1a for multiple sclerosis; ALT elevations occurred in 19% of controls and 28% of once weekly and 53-67% of thrice weekly treated patients; ALT elevations were rarely persistent and required discontinuation in <1% of patients; elevations were more frequent among males than females and in those on NSAIDs, but rates did not vary by age, body weight or acetaminophen use; postmarketing surveillance identified 30 cases of hepatotoxicity, 50% with jaundice, 2 requiring liver transplantation).
Leary SM, Miller DH, Stevenson VL, Brex PA, Chard DT, Thompson AJ. Interferon beta-1a in primary progressive MS: an exploratory, randomized, controlled trial. Neurology 2003; 60: 44-51. PIMD: 12525716 (Controlled trial of interferon beta-1a in doses of 30 vs 60 µg weekly for 2 years; ALT elevations above twice ULN occurred in 33% of those given 60 µg, but in none of placebo or 30 µg treated groups; no clinically apparent hepatitis).
Tremlett HL, Yoshida EM, Oger J. Liver injury associated with the beta-interferons for MS: a comparison between the three products. Neurology 2004; 62: 628-31. PIMD: 14981183 (Population based analysis of 846 patients with multiple sclerosis treated with interferon beta-1a or -1b in British Colombia; ALT elevations occurred in 23-39% of patients, but were above 5 times ULN in only 1-2%; 2 patients developed clinically apparent jaundice; no predictors of ALT elevations identified).
Francis GS, Kaplowitz N, Alteri E. Liver injury associated with the beta-interferons for MS. Neurology 2004; 63: 1142-3; author reply 1142-3. PIMD: 15457586 (Letter in response to Tremlett [2004] commenting upon conclusions).
Tremlett HL, Oger J. Elevated aminotransferases during treatment with interferon-beta for multiple sclerosis: actions and outcomes. Mult Scler 2004; 10: 298-301. PIMD: 15222695 (Among 835 patients with multiple sclerosis treated with interferon beta, 34% developed ALT elevations and one acute liver failure [Yoshida 2001]).
Núñez O, de Andrés C, Alvarez E, García-Monzón C, Clemente G. [Autoimmune hepatitis in patients with a diagnosis of multiple sclerosis]. Gastroenterol Hepatol 2004; 27: 521-4. Spanish. PIMD: 15544737 (Two women, ages 25 and 28, with multiple sclerosis but not on interferon beta developed autoimmune hepatitis [bilirubin 3.9 and 7.5 mg/dL, ALT 1146 and 748 U/L, Alk P 151 and 231 U/L, ANA negative], one responding to corticosteroid therapy, the other progressing to hepatic failure and death).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. PIMD: 15390328 (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to interferon beta).
Wallack EM, Callon R. Liver injury associated with the beta-interferons for MS. Neurology 2004; 63: 1142-3; author reply 1142-3. Review. PIMD: 15452330 (52 year old woman developed jaundice 2 weeks after starting different formulation of interferon beta-1a having tolerated other forms of interferon beta-1a and -1b for years [bilirubin 28.6 mg/dL, ANA 1:320], responding to corticosteroids).
Gold R, Rieckmann P, Chang P, Abdalla J; PRISMS Study Group. The long-term safety and tolerability of high-dose interferon beta-1a in relapsing-remitting multiple sclerosis: 4-year data from the PRISMS study. Eur J Neurol 2005; 12: 649-56. PIMD: 16053475 (Controlled trial of 2 doses of interferon beta-1a vs placebo in 560 patients with multiple sclerosis for up to 4 years; ALT elevations occurred in 20-27% of interferon-treated vs 4% of placebo recipients, but was a rare reason for discontinuation).
Pohl D, Rostasy K, Gartner J, Hanefeld F. Treatment of early onset multiple sclerosis with subcutaneous interferon beta-1a. Neurology 2005; 64: 888-90. PIMD: 15753430 (Trial of interferon beta-1a in 51 patients with early onset multiple sclerosis; ALT elevations occurred in 27%, usually mild and resolving spontaneously).
Sandberg-Wollheim M, Bever C, Carter J, Farkkila M, Hurwitz B, Lapierre Y, et al.; EVIDENCE Study Group. Comparative tolerance of IFN beta-1a regimens in patients with relapsing multiple sclerosis. The EVIDENCE study. J Neurol 2005; 252: 8-13. PIMD: 15654549 (Controlled trial of two dose regimens of interferon beta-1a for multiple sclerosis; ALT elevations occurred in 65% of those on 44 µg thrice weekly vs 41% on 30 µg once weekly; while ALT levels above 5 times ULN occurred in 3.2% vs 1.8%).
Yuce B, Gulberg V, Diebold J, Gerbes AL. Hepatitis induced by Noni juice from Morinda citrifolia: a rare cause of hepatotoxicity or the tip of the iceberg? Digestion 2006; 73 (2-3): 167-70. PIMD: 16837801 (24 year old woman with multiple sclerosis developed jaundice 10 weeks after starting interferon beta-1a [bilirubin 5.25 mg/dL, ALT 1538 U/L], with worsening over the following week; patient then found to be taking "noni" juice and upon stopping began to improve).
West BJ. Hepatotoxicity from interferon-beta, not noni juice. Digestion 2006; 74: 47-8. PIMD: 17068398 (Letter in response to Yuce [2006] suggesting that interferon beta rather than noni juice was the cause of the liver injury).
Byrnes V, Afdhal N, Challies T, Greenstein PE. Drug induced liver injury secondary to interferon-beta (IFN-ß) in multiple sclerosis. Ann Hepatol 2006; 5: 56-9. PIMD: 16531969 (Three cases of interferon beta hepatotoxicity with autoimmune features; 37 year old with multiple sclerosis developed jaundice and pruritus 10 months after starting interferon beta-1a [bilirubin 11.9 mg/dL, ALT 1031 U/L, ANA 1:40], with resolution in 8 weeks despite continuing therapy, later developing recurrence when switched to another formulation of interferon beta, ultimately being treated successfully for autoimmune hepatitis; 37 year old developed fever and ALT elevation [230 U/L, ANA negative] within 3 weeks of starting interferon beta, values rising for 3 weeks after stopping [ALT 914 U/L], improving rapidly with prednisone therapy; 30 year old developed ALT elevations [235 U/L, ANA 1:160] 9 weeks after starting interferon beta, with ALT levels remaining high for 6 weeks after stopping).
Pulichen M, Koteish A, DeBusk K, Calabresi PA. Unmasking of autoimmune hepatitis in a patient with MS following interferon beta therapy. Neurology 2006; 66: 1954-5. PIMD: 16801674 (43 year old woman developed abdominal pain 6 weeks after starting interferon beta-1a [bilirubin 0.5 mg/dL, ALT 391 U/L], with little change one and two weeks after stopping [bilirubin 1.4 and 4.2 mg/dL, ALT 864 and 1270 U/L, ANA 1:40 and SMA 1:80], treated with corticosteroids and improved, later stopping immunosuppression and tolerating glatiramer acetate therapy of multiple sclerosis).
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. PIMD: 16054882. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; beta interferon did not rank among the 21 drugs linked to more than 50 cases).
Montero JL, Cerezo A, Fraga E, Barrera P, López-Cillero P, Costán G, Poyato A, et al. Acute liver failure in a patient with multiple sclerosis treated with interferon-beta. Mult Scler 2007; 13: 820. PIMD: 17613614 (39 year old woman with multiple sclerosis developed jaundice after 5 years of interferon beta [β-1b] therapy [bilirubin 10.4 mg/dL, ALT 1082 U/L, Alk P 176 U/L, protime 26%, ANA 1:1260], with progression to acute liver failure and transplantation on day 14 [explants showing massive necrosis]).
Grieco A, Montalto M, Vero V, Maria Vecchio F, Gasbarrini G. Severe acute hepatitis after resumption of interferon-Beta therapy for multiple sclerosis: a word of caution. Am J Gastroenterol 2007; 102: 2606-7. PIMD: 17958769 (43 year old woman with multiple sclerosis developed jaundice 2 weeks after restarting interferon beta [bilirubin 12.5 mg/dL, ALT 995 U/L, Alk P 695 U/L, ANA negative], the agent having been stopped the year before because of ALT elevations [~600 U/L] after 2 years of use).
Behrbolm J, Neid M, Stolzel U, Wittekind C, Hauss JP, Tillmann HL. Improvement of multiple sclerosis on tacrolimus plus mycophenolate mofetil after liver transplantation. Transplant Int 2007; 20: 1077-9. PIMD: 17937765 (51 year old woman with multiple sclerosis developed jaundice 8 weeks after starting interferon beta [36.9 mg/dL, INR 1.7, ANA 1:160], progressing to liver failure and transplantation 3 days later; explant histology suggested autoimmune hepatitis).
Pietrosi G, Mandala L, Vizzini GB, Gruttadauria S, Minervini MI, Burgio G, Spadaro A, et al. Fulminant hepatic failure and autoimmune disorders in patient with multiple sclerosis on interferon beta 1a: a fatal combination? Transpl Int 2008; 21: 502-4. PIMD: 18167153 (46 year old woman developed jaundice 2.5 years after starting interferon beta for multiple sclerosis [bilirubin 15.2 mg/dL, ALT 1232 U/L, Alk P 221 U/L, ANA negative, SMA 1:80], with progression to hepatic failure and liver transplantation, biopsy showing submassive necrosis).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. PIMD: 18955056 (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to interferon beta, ranking 5th).
Hotermans C, Belachew S, Moonen G, Delwaide J. Severe liver dysfunction in a patient with multiple sclerosis: the guilty party is not always the disease-modifying therapy. Multiple Sclerosis 2009; 15: 1378-9. PIMD: 19965562 (38 year old with multiple sclerosis developed pruritus and jaundice 7 weeks after starting interferon beta-1a [bilirubin not given; ALT 1788 U/L, ANA negative], with rapid resolution; recurrence of liver injury arose 3 days after starting glatiramer acetate [ALT 749 U/L, ANA negative] and rapid resolution; both episodes were also associated with ibuprofen use).
O'Connor P, Filippi M, Arnason B, Comi G, Cook S, Goodin D, Hartung HP, et al. 250 microg or 500 microg interferon beta-1b versus 20 mg glatiramer acetate in relapsing-remitting multiple sclerosis: a prospective, randomised, multicentre study. Lancet Neurol 2009; 8: 889-97. PIMD: 19729344 (Controlled trial of two doses of interferon beta-1b versus glatiramer in 2447 patients with multiple sclerosis, ALT elevations occurred in 11-16% of interferon beta and 4% of glatiramer treated subjects; no mention of clinically apparent liver injury).
Paolicelli D, Direnzo V, Trojano M. Review of interferon beta-1b in the treatment of early and relapsing multiple sclerosis. Biologics 2009; 3: 369-76. PIMD: 19707422 (Review of efficacy and safety of interferon beta in multiple sclerosis; elevations in serum enzymes are more common during interferon beta than glatiramer therapy).
Interferon beta-1b (Extavia) for multiple sclerosis. Med Lett Drugs Ther 2010; 52: 86-7. PIMD: 21045760 (Concise review of efficacy and safety of interferon beta-1b (Extavia) shortly after its approval in the US; mentions that hepatic enzyme elevations may occur).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. PIMD: 20949552 (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury of which one was linked to interferon beta).
Czaja AJ. Drug-induced autoimmune-like hepatitis. Dig Dis Sci 2011; 56: 958-76. PIMD: 21327704 (Review of drug induced autoimmune hepatitis, the principal causes being minocycline and nitrofurantoin; other causes being methyldopa, hydralazine, statins, fibrates, diclofenac, anti-TNF agents, interferons, propylthiouracil, and isoniazid).
Chan S, Kingwell E, Oger J, Yoshida E, Tremlett H. High-dose frequency beta-interferons increase the risk of liver test abnormalities in multiple sclerosis: a longitudinal study. Mult Scler 2011; 17: 361-7. PIMD: 21148660 (Retrospective analysis of 802 patients with multiple sclerosis treated with interferon beta between 1995-2005; 39% had ALT elevations at least once, 13% were above 2 times ULN, 2.1% above 5 times ULN and 29.5% led to discontinuation; elevations were more common if interferon beta was given several times per week or daily compared to weekly).
Tremlett H, Fu P, Yoshida E, Hashimoto S. Symptomatic liver injury (hepatotoxicity) associated with administration of complementary and alternative products (Ayurveda-AP-Mag Capsules(®)) in a beta-interferon-treated multiple sclerosis patient. Eur J Neurol 2011; 18: e78-9. PIMD: 21658156 (38 year old woman with multiple sclerosis on long term beta interferon therapy developed pruritus and fatigue one month after starting a mixture of herbal medicines [bilirubin 1.2 mg/dL, ALT 886 U/L, Alk P 71 U/L], resolving within a month of stopping both the beta interferon and the herbals).
Tamura S, Warabi Y, Matsubara S. Severe liver dysfunction possibly caused by the combination of interferon beta-1b therapy and melilot (sweet clover) supplement. J Clin Pharm Ther 2012; 37: 724-5. PIMD: 22642738 (23 year old woman with multiple sclerosis developed ALT elevations 14 days after starting every other day beta interferon injections while also taking "sweet clover" [ALT 681 U/L, bilirubin and Alk P not given], abnormalities resolving within a month of stopping both agents and not recurring when beta interferon was restarted at a lower dose).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 ; 144: 1419-25. PIMD: 23419359 (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 1 attributed to interferon beta, out of only 145 persons receiving this medication in Iceland).
Fontana RJ, Hayashi P, Bonkovsky HL, Kleiner DE, Kochhar S, Gu J, Ghabril M. Presentation and outcomes with clinically apparent interferon beta hepatotoxicity. Dig Dis Sci 2013; 58: 1766-75. PIMD: 23377559 (Among 784 cases of drug induced liver injury enrolled in a prospective cohort in the US from 2004-2010, 8 [1%] were attributed to beta interferon; all 8 were women, ages 33-64 years, who had been on interferon for 3 months to 13 years and presented with a hepatocellular or mixed pattern of injury, none with autoantibodies, 4 with jaundice, 5 resolved and 1 was fatal: Cases 1, 2 and 3).
Kowalec K, Yoshida EM, Traboulsee A, Carleton B, Tremlett H. Suspected autoimmune hepatitis and primary biliary cirrhosis unmasked by interferon-beta in a multiple sclerosis patient. Mult Scler Relat Disord 2013; 2: 57-9. PIMD: 25877455 (42 year old woman developed abnormal liver tests 34 months after starting a second course of beta interferon [bilirubin 0.5 mg/dL, ALT 260 U/L, Alk P 157 U/L, ANA and AMA 1:1280], with resolution within 2 months although autoantibodies persisted).
Kowalec K, Kingwell E, Yoshida EM, Marrie RA, Kremenchutzky M, Campbell TL, Wadelius M,et al. Characteristics associated with drug-induced liver injury from interferon beta in multiple sclerosis patients. Expert Opin Drug Saf 2014; 13: 1305-17. PIMD: 25134421 (Among 942 patients with relapsing multiple sclerosis treated with beta interferon in British Columbia, Canada, 18 [2%] developed ALT elevations above 5 times ULN, all within 2 years of starting but only 3 were symptomatic, none were jaundiced, and all resolved, some without discontinuing therapy).
Kozielewicz D, Pawłowska M. Acute liver failure and liver transplantation in a patient with multiple sclerosis treated with interferon beta. Neurol Neurochir Pol 2015; 49: 451-5. PIMD: 26652882 (41 year old woman with relapsing multiple sclerosis developed jaundice 4 weeks after starting beta interferon [bilirubin 17.7 mg/dL, ALT 1045 U/L, Alk P 137 U/L, INR 2.37], with progressive worsening and successful, emergency liver transplant 1 week later).
Villamil A, Mullen E, Casciato P, Gadano A. Interferon beta 1a-induced severe autoimmune hepatitis in patients with multiple sclerosis: report of two cases and review of the literature. Ann Hepatol 2015; 14: 273-80. PIMD: 25671839 (2 patients with relapsing multiple sclerosis developed serious liver injury after restarting beta interferon, both recovering with corticosteroid therapy; 20 year old woman developed jaundice after 3 weeks of beta interferon and methylprednisolone [bilirubin peak 19.3 mg/dL, ALT 710 U/L, Alk P 192 U/L, ANA negative], and 47 year old man developed abnormal liver tests 1 month after restarting beta interferon [bilirubin 3.4 mg/dL, ALT 2209 U/L, Alk P 101 U/L, ANA 1:320]).
Mishra A, Guindi M, Kandel G, Streutker CJ. Autoimmune hepatitis-like reaction developing in a patient treated with interferon-β1a. Histopathology 2015; 66: 605-7. PIMD: 24796493 (43 year old woman with relapsing multiple sclerosis developed abnormal liver tests 3 months after starting beta interferon [bilirubin not given, ALT 408 U/L, Alk P 87 U/L, ANA negative], resolving within 7 weeks of stopping).
Peginterferon beta-1a (Plegridy) for multiple sclerosis. Med Lett Drugs Ther 2015; 57 (1468): 67-9. PIMD: 25941954 (Concise review of efficacy, safety and costs of peginterferon beta-1a shortly after its approval for use in multiple sclerosis in the US, mentions that injection site reactions and influenza-like symptoms are common adverse effects, but does not mention ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. PIMD: 25754159 (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 7 [0.8%] were attributed to interferon beta, although none of the cases were linked specifically to its pegylated formulation).
Makioka H, Nakaya F, Ling Y, Torii S, Saida T, Kira JI. Safety and effectiveness of interferon β-1a intramuscular therapy: results of the postmarketing drug surveillance in Japan. Rinsho Shinkeigaku 2017; 57: 553-61. PIMD: 28966229 (Analysis of 1441 patients treated with interferon beta-1a in a postmarketing surveillance study from Japan found severe abnormal liver function in 10 cases [0.8%]).
Yamazaki Y, Suzuki A, Hirayanagi K, Tsukagoshi Y, Uehara R, Horiguchi K, Ohyama T, et al. An autopsy case of fulminant hepatitis in a patient with multiple sclerosis treated by interferon-beta-1a. Intern Med 2017; 56: 1897-1901. PIMD: 28717089 (49 year old woman with relapsing multiple sclerosis developed jaundice 2-3 weeks after starting interferon beta [bilirubin 18.1 mg/dL, ALT 1402 U/L, Alk P 661 U/L, ANA 1:40, prothrombin index <10%], dying 7 days after admission).
Kowalec K, Wright GEB, Drögemöller BI, Aminkeng F, Bhavsar AP, Kingwell E, Yoshida EM, et al. Common variation near IRF6 is associated with IFN-β-induced liver injury in multiple sclerosis. Nat Genet. 2018;50:1081-1085. PIMD: 30013178. (In a genome wide association study of 56 patients of European ancestry with multiple sclerosis and interferon-beta associated liver injury and 126 interferon beta treated controls without liver injury, a common variation on chromosome 11 near the gene for interferon regulatory factor 6 was more frequent in those with liver injury [MAF 0.21 vs 0.03, number of patients with the allele was not provided).
Diebold M, Fischer-Barnicol B, Tsagkas C, Kuhle J, Kappos L, Derfuss T, Décard BF. Hepatitis E virus infections in patients with MS on oral disease-modifying treatment. Neurol Neuroimmunol Neuroinflamm. 2019;6:e594. PIMD: 31454772. (Four of more than 1000 patients with multiple sclerosis followed in a Swiss referral center between 2016 and 2018 developed acute hepatitis E while on immunomodulatory agents capable of causing drug-induced liver injury, all recovering without antiviral therapy).
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640. PIMD: 30230957. (Among 4873 cases of severe liver injury attributed to agents used to treat multiple sclerosis reported to the FDA’s Adverse Event Reporting System between 2004 and 2016, the most frequently implicated agents were interferon-beta1a [n=2343], natalizumab [n=759], interferon beta1b [535], fingolimod [496], dimethyl fumarate [223], glatimer acetate [212] and teriflunomide [158].
Cohen JA, Comi G, Selmaj KW, Bar-Or A, Arnold DL, Steinman L, Hartung HP, et al.; RADIANCE Trial Investigators. Safety and efficacy of ozanimod versus interferon beta-1a in relapsing multiple sclerosis (RADIANCE): a multicentre, randomised, 24-month, phase 3 trial. Lancet Neurol. 2019;18:1021-1033. PIMD: 31492652. (Among 1320 patients with relapsing multiple sclerosis treated with ozanimod [0.5 or 1.0 mg once daily] or interferon beta-1a [30 mcg im weekly] for 24 months, the annualized rate of relapse was lower with ozanimod [0.17 and 0.22 vs 0.28] while adverse event rates were less [75% and 74% vs 83%], although severe event rates were similar and ALT elevations above 3 times the ULN were more frequent [6.7% and 5.9% vs 3.9%]).
Capone F, De Vincentis A, Ferraro E, Rossi M, Motolese F, Picardi A, Giannetti B, et al. The PNPLA3 rs738409 variant can increase the risk of liver toxicity in multiple sclerosis patients treated with beta-interferon. Clin Neurol Neurosurg. 2020;197:106166. PIMD: 32877766. (Among 113 patients with multiple sclerosis who were treated with interferon beta, 29 who had mild or moderate “liver toxicity” were more like to have the hepatic steatosis-associated G allele of PNPLA3 than the 84 without liver injury [GG in 14% vs 10%, CG in 55% vs 38%, and CC in 31% vs 52%] although the differences were not statistically significant except after post-hoc regression analysis).
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880. PIMD: 34319570. (Extensive review of the liver injury associated with disease modifying therapies of multiple sclerosis concludes that none of the agents in current use are free of potential hepatic toxic effects, that patients should be informed of this potential complication of therapy, and alerted to report symptoms of liver injury promptly).
Daly AK. Genetics of drug-induced liver injury: current knowledge and future prospects. Clin Transl Sci. 2023;16:37-42. PIMD: 36194091. (Concise review of the genetic associations found with various agents that cause drug-induced liver injury, most prominently HLA associations such as HLA-B*57:01 with flucloxacillin and HLA-A*02:01 and several non-HLA associations with amoxicillin/clavulanate although none of the reported associations has sufficient predictive value to be useful in screening to prevent toxicity).
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, et al. Adverse events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006. PIMD: 38181306. (In an analysis of 35,894 patients with multiple sclerosis living in 4 Canadian providences, electronic medical records were used to assess potential long-term adverse effects of 7 disease modifying drugs, but because there were only 6 instances of acute liver injury, risk assessment was not very rigorous, and increase risks were found only for dimethyl fumarate and alemtuzumab).
Dumitru-Martoiu MM, Petrescu S, Panea CA. Etiopathogenic and therapeutic considerations in a multiple sclerosis case with acute toxic hepatitis. Reports (MDPI). 2025;8:38. PIMD: 40710829. (39 year old woman with a 12 year history of multiple sclerosis on natalizumab for more than a year developed jaundice a month after starting ashwagandha and after 7 days of taking acetaminophen frequently [bilirubin 7.6 mg/dL, ALT 2120 U/L, AST 1208 U/L, Alk P 247 U/L, INR not given] with rapid improvement on stopping and starting corticosteroids, liver tests being normal one month later and remained normal after restarting natalizumab).
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. PIMD: 38992407. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, none were attributed to interferon-beta but single instances of liver injury were due to natalizumab and fingolimod [personal communication]).

## OTHER REFERENCE LINKS

1. Recent References on Interferon beta-1a/1b: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=interferon+beta/AE+AND+(interferon+beta+1b+%5BNM%5D+OR+interferon+beta+1a+%5BNM%5D)+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222007/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Interferon beta-1a/1b: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=interferon+beta)